# Vitamin D

## OVERVIEW

### Introduction

Vitamin D is a fat soluble vitamin important in the regulation of calcium metabolism and bone health and deficiency of which cause rickets, a disease marked by lack of mineralization of bone. Conventional doses of vitamin D are well tolerated without appreciable adverse effects. High doses of vitamin D can be toxic, leading to a constellation of signs and symptoms but not liver injury or jaundice.

### Background

Vitamin D is typically referred to as a fat soluble vitamin, but actually represents two related fat soluble substances cholecalciferol (koe" le kal sif' er ol: vitamin D3) and ergocalciferol (er" goe kal sif’ er ol: vitamin D2), both of which can be used to cure or prevent rickets. These molecules are made from 7-dehydrocholesterol, referred to as pro-vitamin D, which is activated to vitamin D by ultraviolet light, generally in the dermis or epidermis. These sterols are then transported to the liver where they undergo 25-hydroxylation (to 25-OH vitamin D) and then to the kidney where they undergo a second hydroxylation to the fully active molecules: 1,25 dihydroxycholecalciferol (vitamin D3, calcitriol) and 1,25 dihydroxyergocalciferol (vitamin D2). Vitamin D is not a vitamin in the usual sense, in that humans synthesize adequate amounts given adequate exposure to sunlight. Furthermore, vitamin D acts more like a hormone than a vitamin. It acts by binding to specific cytosolic receptors, not only in intestinal epithelial cells and in osteocytes, but also in multiple other tissues such as hematopoietic cells, hair follicles, adipose tissue, muscles and brain. After binding to its cytosolic receptors, vitamin D is translocated to the nucleus where the vitamin-receptor complex interacts with DNA and modulates gene expression to increase calcium absorption. The effect of vitamin D on bone is complex, in that it directly causes mobilization of calcium and bone resorption. The effect of vitamin D on bone mineralization is indirect, being mediated by the increase in calcium absorption from the intestine. While the major effects of vitamin D are on calcium absorption and bone resorption, it clearly has many other activities, the clinical implications of which are not all fully known. Vitamin D is available in multiple forms, including tablets, capsules, oral solutions and syrups and solutions for injection; by prescription and over-the-counter; alone or in combination with calcium or in combination with other vitamins; as cholecalciferol, ergocalciferol and their hydroxylated forms as well as synthetic analogues. Common commercial (and generic) names include Rocaltrol (calcitriol), One-Alpha (alfacalcidol), Calderol (calcifediol), Caltrate (cholecaliciferol), Hectorol (doxercalcifedol), Calcidol (ergocalciferol) and Zemplar (paricalcitol). The recommended daily allowance (RDA) for vitamin D has been recently modified and is 600 IU (~15 µg) in persons 1 to 70 years of age and 800 IU (~20 µg) daily for those 71 years and older. An adequate blood level of vitamin D (measured as 25-OH vitamin D) is considered 20 ng/mL (50 nmol/L) and above, a level that can be achieved by most people through daily skin exposure to light. Levels above 60 ng/mL (150 nmol/L) are considered excessive and referred to as “hypervitaminosis D”. Levels above 150 ng/mL (375 nmol/L) generally lead to symptoms and signs of toxicity which is referred to as “vitamin D intoxication”.

### Hepatotoxicity

Neither normal nor excessively high intakes of vitamin D are associated with liver injury or liver test abnormalities. Hypervitaminosis D and vitamin D intoxication generally arise with intakes above 50,000 IU daily, but lower doses may induce toxicity in susceptible individuals such as patients with renal osteodystrophy (secondary hyperparathyroidism), and a safer upper limit of recommended intake is 10,000 IU daily. Symptoms of vitamin D intoxication are caused by hypercalcemia and can include dehydration, thirst, polyuria, anorexia, nausea, vomiting, constipation, fatigue, bone pains and muscle cramps. Complications can include renal dysfunction, nephrocalcinosis, decreased consciousness and seizures. Symptoms arise a few weeks to several months after starting excess doses of vitamin D given orally or parenterally. A common cause of hypervitaminosis D is the mislabeling of an over-the-counter or locally prepared nutritional supplement, excessive fortification of milk or foods, and inadvertent prescription or dispensing errors. In clinical descriptions of vitamin D intoxication, typical laboratory findings are hypercalcemia, increase in serum creatinine, and high 25-OH vitamin D levels (usually above 200 ng/mL or 500 nmol/L). Serum aminotransferase and bilirubin levels are typically normal, while alkaline phosphatase levels may actually be lower than normal.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Vitamin D in high doses increases absorption of dietary calcium, but also mobilizes calcium from bone. The symptoms of vitamin D intoxication are largely those of hypercalcemia. While hepatocytes, cholangiocytes, stellate cells and resident immune cells in the liver have vitamin D receptors, there is no evidence that vitamin D causes injury to the liver.

Drug Class: Vitamins

Other Drugs in the Class: Vitamin A, Vitamin B, Vitamin C, Vitamin E, Vitamin K, Folate, Niacin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vitamin D – Generic, Rocaltrol® (Calcitriol, Vitamin D3)

DRUG CLASS

Vitamins

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vitamin+D)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Cholecalciferol | 67-97-0 | C27-H44-O
Ergocalciferol | 50-14-6 | C28-H44-O

## ANNOTATED BIBLIOGRAPHY

References updated: 27 May 2021

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999; does not discuss vitamin D).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp, 631-57. (Review of hepatotoxicity of dietary supplements; does not discuss vitamins and minerals).
Nolin TD, Friedman PA. Agents affecting mineral ion homeostasis and bone turnover. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 887-906. (Textbook of pharmacology and therapeutics).
Holick MF. Vitamin D. In, Shils ME, Olson JA, Shike M, Ross AC, eds. Modern nutrition in health and disease. 9th ed. Baltimore: Williams & Wilkins, 1998: pp. 329-46. (Textbook of nutrition).
Food and Nutrition Board, Institute of Medicine. DRI dietary reference intakes for calcium and vitamin D. Washington DC: National Academy Press, 1998. (Reports from the Food and Nutrition Board of the Institute of Medicine on reference values for vitamin intake, replacing the previously published Recommended Dietary Allowances).
Office of Dietary Supplements. https://ods.od.nih.gov/factsheets/VitaminD-HealthProfessional/ (Fact sheet on vitamin D maintained and regularly updated by the Office of Dietary Supplements, National Institutes of Health).
Jacobus CH, Holick MF, Shao Q, Chen TC, Holm IA, Kolodny JM, Fuleihan GE, et al. (1992). Hypervitaminosis D associated with drinking milk. N Engl J Med. (Eight patients including a 15 month old child who were not taking vitamin D supplements were found to have hypervitaminosis D, 7 with hypercalcemia, 5 with elevated creatinine and all with high 25-OH vitamin D [207-1660 nmol/L] and all drank milk from the same local dairy; testing of the milk showed high, but variable levels of cholecalciferol).
Blank S, Scanlon KS, Sinks TH, Lett S, Falk H. (1995). An outbreak of hypervitaminosis D associated with the overfortification of milk from a home-delivery dairy. Am J Public Health. (Case control study of 33 cases of hypervitaminosis D and 93 controls found risk factors of vitamin D supplementation, older age and increasing consumption of milk from a local dairy, which had been implicated in 8 cases previously [Jacobus 1992]).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to vitamins including vitamin D).
Kaptein S, Risselada AJ, Boerma EC, Egbers PH, Nieboer P. (2010). Life-threatening complications of vitamin D intoxication due to over-the-counter supplements. Clin Toxicol (Phila). (75 and 73 year old women presented with severe hypercalcemia [16.0 and 18.2 mg/dL] and hypervitaminosis D [1,372 and 644 nmol/L] while taking a dietary supplement labelled as having 150 IU of vitamin D, which on testing had 100-1000 times that concentration).
Araki T, Holick MF, Alfonso BD, Charlap E, Romero CM, Rizk D, Newman LG. (2011). Vitamin D intoxication with severe hypercalcemia due to manufacturing and labeling errors of two dietary supplements made in the United States. J Clin Endocrinol Metab. (Two men, ages 58 and 40 years, presented with hypercalcemia 1 and 2 months after starting commercial multivitamin pills which on testing had higher levels of vitamin D than stated on the label [186,400 instead of 1600 IU, and 970,000 instead of 1000 IU], with slow resolution after stopping; no mention of ALT elevations or hepatotoxicity).
Jacobsen RB, Hronek BW, Schmidt GA, Schilling ML. (2011). Hypervitaminosis D associated with a vitamin D dispensing error. Ann Pharmacother. (70 year old woman with multiple medical conditions was treated with calcium and cholecalciferol [1000 IU daily] but was mistakenly given ergocalciferol [50,000 IU] to take daily and developed fatigue and confusion 3 months later [calcium 14.6 mg/dL, creatinine 5.3 mg/dL, Alk P 82 U/L], resolving with hydration and stopping calcium and vitamin D supplements).
Lowe H, Cusano NE, Binkley N, Blaner WS, Bilezikian JP. (2011). Vitamin D toxicity due to a commonly available "over the counter" remedy from the Dominican Republic. J Clin Endocrinol Metab. (9 patients presented with hypercalcemia and hypervitaminosis D after starting an over-the-counter supplement that had higher concentrations of vitamin D than stated on the label [864,000 rather than 600,000 IU]).
Ross AC, Manson JE, Abrams SA, Aloia JF, Brannon PM, Clinton SK, Durazo-Arvizu RA, et al. (2011). The 2011 report on dietary reference intakes for calcium and vitamin D from the Institute of Medicine: what clinicians need to know. J Clin Endocrinol Metab. (Summary of the 2011 report on reference intakes for calcium and vitamin D recommends intake of 600 IU daily for ages 1 to 70 and 800 IU daily for age above 71 years attempting to achieve serum 25-OH vitamin D levels of at least 20 ng/mL or 50 nmol/L).
Pandita KK, Razdan S, Kudyar RP, Beigh A, Kuchay S, Banday T. (2012). "Excess gooD can be Dangerous". A case series of iatrogenic symptomatic hypercalcemia due to hypervitaminosis D. Clin Cases Miner Bone Metab. (Case series of 15 adults [ages 42 to 85 years] with hypervitaminosis D after taking vitamin D3 injections for 5 weeks to 3 years [calcium 11.0 to 15.2 mg/dL, creatinine 1.1 to 3.5 mg/dL, 25OH-vitamin D 103 to 164 ng/mL]).
Ozkan B, Hatun S, Bereket A. (2012). Vitamin D intoxication. Turk J Pediatr. (Review of the clinical features, diagnosis, laboratory investigation and treatment of vitamin D intoxication; no mention of liver involvement but states that alkaline phosphatase levels tend to be low or normal).
Vanstone MB, Oberfield SE, Shader L, Ardeshirpour L, Carpenter TO. (2012). Hypercalcemia in children receiving pharmacologic doses of vitamin D. Pediatrics. (Three infants developed hypercalcemia while being treated for vitamin D deficiency, responding to stopping excessive pharmacologic doses [1400-2000 IU daily], and one later tolerating doses within the RDA [600 IU daily]).
Fortmann SP, Burda BU, Senger CA, Lin JS, Beil TL, O'Connor E, Whitlock EP. Vitamin, mineral, and multivitamin supplements for the primary prevention of cardiovascular disease and cancer: a systematic evidence review for the U.S. Preventive Services Task Force [Internet]. Rockville (MD): Agency for Healthcare Research and Quality (US); 2013 Nov. Available from http://www.ncbi.nlm.nih.gov/books/NBK173987/ (Systematic review of the efficacy and safety of vitamin D in the prevention of cardiovascular disease and cancer states that most trials showed no differences in side effects between vitamin D and placebo).
Anık A, Çatlı G, Abacı A, Dizdarer C, Böber E. (2013). Acute vitamin D intoxication possibly due to faulty production of a multivitamin preparation. J Clin Res Pediatr Endocrinol. (Three infants, ages 1 to 2 years, presented with severe hypercalcemia [19.4, 19.3 and 13.7 mg/dL], nephrocalcinosis and toxic levels of 25-OH vitamin D [>160 nmol/L] after taking a commercial multivitamin preparation labeled as having 200 IU of vitamin D, but suspected of having more).
Nasri H, Mubarak M. (2013). Renal injury due to vitamin D intoxication; a case of dispensing error. J Renal Inj Prev. (56 year old man developed hypercalcemia, interstitial nephritis and renal insufficiency after given 40 [instead of the prescribed 6] injections of vitamin D [300,000 IU] weekly [calcium 12 mg/dL, creatinine 4.0 mg/dL, 25OH-vitamin D >400 nmol/L]).
Kara C, Gunindi F, Ustyol A, Aydin M. (2014). Vitamin D intoxication due to an erroneously manufactured dietary supplement in seven children. Pediatrics. (Seven children [ages 0.7 to 4.2 years] presented with symptomatic hypercalcemia [13.4-18.8 mg/dL] and high 25-OH vitamin D levels [340-962 ng/mL] and were found to have taken an over-the-counter fish oil supplement, labelled as having 200 IU of vitamin D per dose, but measured as having ~800,000 IU; all recovering with medical management).
Bansal RK, Tyagi P, Sharma P, Singla V, Arora V, Bansal N, Kumar A, Arora A. (2014). Iatrogenic hypervitaminosis D as an unusual cause of persistent vomiting: a case report. J Med Case Rep. (45 year old woman developed polydipsia, anorexia, nausea and recurrent vomiting with hypercalcemia [11.5 mg/dL] and renal dysfunction [creatinine 4.1 mg/dL] after receiving ten intramuscular injections of vitamin D [600,000 IU each] with normal liver tests [bilirubin 0.6 mg/dL, ALT 22, AST 20 U/L] but slightly elevated alkaline phosphatase [221 U/L], responding to hydration and low calcium diet).
Conti G, Chirico V, Lacquaniti A, Silipigni L, Fede C, Vitale A, Fede C. (2014). Vitamin D intoxication in two brothers: be careful with dietary supplements. J Pediatr Endocrinol Metab. (15 and 12 year old brothers presented with hypervitaminosis D after taking a locally prepared cod liver oil supplement for 15 and 30 days [calcium 9.8 and 15.7 mg/dL, creatinine 0.7 and 2.3 mg/dL, 25-OH vitamin D 138 and 214 nmol/L], resolving slowly upon stopping).
Bala S, Shah B, Rajput P, Rao P. (2015). Unmasking of primary hyperparathyroidism by Vitamin D therapy. Indian J Nephrol. (38 year old woman developed hypercalcemia [15.9 mg/dL] 2 months after starting vitamin D [60,000 IU weekly], but was also found to have hyperparathyroidism [bilirubin 0.8 mg/dL, ALT 23 U/L, iPTH 1464 pg/mL], which resolved after removal of a parathyroid adenoma).
McKenna MJ, Murray BF, O'Keane M, Kilbane MT. (2015). Rising trend in vitamin D status from 1993 to 2013: dual concerns for the future. Endocr Connect. (Analysis of serum 25-OH vitamin D levels among 43,782 Irish patients over a 20 year period showed increases in mean levels and lower rates of deficiency in 2013 vs 1993-94 [<10 nmol/L in 2.7% vs 15.3%], but also higher rates of excessive levels [>125 nmol/L in 3.8% vs 0.7%]).
Chakraborty S, Sarkar AK, Bhattacharya C, Krishnan P, Chakraborty S. (2015). A nontoxic case of vitamin D toxicity. Lab Med. (42 year old woman mistakenly took 60,000 IU of vitamin D daily instead of weekly as prescribed and was found to have high levels of serum vitamin D [25-OH vitamin D 670 ng/mL], but without symptoms or hypercalcemia [9.0 mg/dL], liver tests were also normal).
Stickel F. (2015). Shouval. Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol. (Review of the hepatotoxicity of herbal and nutritional supplements; does not mention or discuss vitamin D).
Ketha H, Wadams H, Lteif A, Singh RJ. (2015). Iatrogenic vitamin D toxicity in an infant--a case report and review of literature. J Steroid Biochem Mol Biol. (4 month old infant presented with dehydration, hypercalcemia [18.7 mg/dL], and nephrocalcinosis, having been given high doses of vitamin D by her breast feeding mother using an over-the-counter product that on testing had higher concentrations than stated on the label [6000 instead of 2000 IU per drop]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 were attributed to niacin but none to any other vitamin, including vitamin D).
Manson JE, Bassuk SS. (2015). Vitamin D research and clinical practice: at a crossroads. JAMA. (Commentary on increased rates of testing for 25-OH vitamin D levels and use of vitamin D supplements in clinical practice stressing that clinical enthusiasm for use of vitamin D has outpaced the medical evidence for its benefit, particularly for non-bone effects).
Pérez-Barrios C, Hernández-Álvarez E, Blanco-Navarro I, Pérez-Sacristán B, Granado-Lorencio F. (2016). Prevalence of hypercalcemia related to hypervitaminosis D in clinical practice. Clin Nutr. (Serum 25-OH vitamin D levels were elevated in 475 of 25,567 samples [1.9%] tested in a single laboratory over a 6 year period in Madrid, Spain, but only 10% of samples were associated with hypercalcemia).
DeLuca HF, Vitamin D. (2016). Historical Overview. Vitam Horm. (Review of the discovery of vitamin D, isolation of its active forms, elucidation of its metabolism and mechanism of action, discovery of the vitamin D receptor and discussion of its multiple actions and effects).
Barchetta I, Del Ben M, Angelico F, Di Martino M, Fraioli A, La Torre G, Saulle R, et al. (2016). No effects of oral vitamin D supplementation on non-alcoholic fatty liver disease in patients with type 2 diabetes: a randomized, double-blind, placebo-controlled trial. BMC Med. (Among 65 patients with diabetes and nonalcoholic fatty liver treated with cholecalciferol [2000 IU/day] vs placebo for 24 weeks, changes in ALT, serum lipids, HbA1c and cytokine levels and measures of visceral or total fat were similar in the two groups).
Kimball SM, Mirhosseini N, Holick MF. (2017). Evaluation of vitamin D3 intakes up to 15,000 international units/day and serum 25-hydroxyvitamin D concentrations up to 300 nmol/L on calcium metabolism in a community setting. Dermatoendocrinol. (Among 3882 adults in a community based study of vitamin D supplementation in doses of 1000-15,000 IU per day [aiming to raise serum 25-OH vitamin D levels to above 100 nmol/L] there were no serious adverse events and mean serum calcium did not change and ALT and GGT levels decreased slightly).
Manson JE, Cook NR, Lee IM, Christen W, Bassuk SS, Mora S, Gibson H, et al., VITAL Research Group. (2019). Vitamin D supplements and prevention of cancer and cardiovascular disease. N Engl J Med. (Among 25,871 adults treated with 2000 IU of cholecalciferol [D3] or placebo daily for a median of 5.3 years, the rates of cardiovascular events and new onset of cancer were the same in the two groups and there were no differences in adverse event rates including hypercalcemia and kidney stones; no specific mention of ALT elevations or hepatotoxicity).
Malihi Z, Wu Z, Lawes CMM, Scragg R. (2019). Adverse events from large dose vitamin D supplementation taken for one year or longer. J Steroid Biochem Mol Biol. (Systematic review of adverse event rates in controlled trials of vitamin D in doses in doses of 2800 IU or more per day for at least 1 year identified 15 studies and no increase in total or severe adverse events associated with vitamin D intake including rates of hypercalcemia).
Pittas AG, Dawson-Hughes B, Sheehan P, Ware JH, Knowler WC, Aroda VR, Brodsky I, et al. (2019). D2d Research Group. Vitamin D supplementation and prevention of type 2 diabetes. N Engl J Med. (Among 2423 adults at high risk of type 2 diabetes treated with vitamin D [4000 IU daily] or placebo for a median of 2.5 years, the rate of new onset diabetes was similar in the two groups as were rates of total and serious adverse events and deaths; no specific mention of ALT levels or hepatotoxicity).
Billington EO, Burt LA, Rose MS, Davison EM, Gaudet S, Kan M, Boyd SK, et al. (2020). Safety of high-dose vitamin D supplementation: secondary analysis of a randomized controlled trial. J Clin Endocrinol Metab. (Among 373 adults [ages 55 to 70 years] treated with one of 3 doses of 25[OH] vitamin D per day for up to 3 years, mild hypercalcemia arose in none on 400 IU, 3% on 4000 IU and 9% on 10,000 IU daily, while adverse event rates were similar in all 3 groups including ALT or AST elevations above 1.5 times the ULN [2%, 2% and 4%] and there were no serious hepatic adverse events).
Bouillon R. (2020). Safety of high-dose vitamin D supplementation. J Clin Endocrinol Metab. (Commentary on the safety and efficacy of high doses of vitamin D summarizing results from 3 recent randomized controlled trials, all of which demonstrated the safety of doses of 3000 to 10,000 IU daily [except for low rates of mild and transient hypercalcemia], but with no evidence of efficacy in reducing the risk of bone fractures, cardiovascular disease, diabetes, or cancer, indicating that doses at or above 4000 IU per day should not be used outside of clinical trials).

## OTHER REFERENCE LINKS

1 Recent References on Vitamin D: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vitamin%20D/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Vitamin D: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vitamin%20D)